# Thiazide Diuretics

## OVERVIEW

### Introduction

The thiazides are the most commonly used oral diuretics and are widely used in the therapy of hypertension and congestive heart failure, as well as the treatment of edema due to local, renal and hepatic causes. Only rare instances of clinically apparent liver injury have been linked to use of thiazide diuretics.

### Background

The benzothiazide diuretics are structurally related drugs that act by inhibition of sodium (and chloride) transport in the distal convoluted tubule by binding to and inhibiting the Na+-Cl- symporter. As a result, there is increased excretion of sodium and water and an associated loss of potassium. Chronic therapy may also result in increased calcium and magnesium loss. The thiazide diuretics are grouped together based upon shared chemical, sulfonamide-like, structure. More recently non-benzothiazide drugs with a similar mechanism of action have been developed (metolazone, indapamide), which are referred to as thiazide-like diuretics. The thiazide and thiazide-like diuretics are all available generically and differ largely in their pharmacokinetic properties of oral availability, relative potency, serum and effective half-life and route of elimination. The general indications for the thiazide diuretics are treatment of hypertension, congestive heart failure and edema.

Thiazide diuretics are available in multiple forms and all are available generically. Bendroflumethiazide (ben' droe floo" me thye' a zide) is available in tablets of 2.5 mg in generic forms; recommended oral doses in adults are 2.5 to 10 mg in two divided doses. It is also available in a fixed dose (5 mg) with nadolol (40 or 80 mg) generically and under the brand name Corzide.

Chlorothiazide (klor" oh thye' a zide) is available in tablets of 250 and 500 mg generically and under the trade name of Diuril; recommended oral doses in adults are 500 to 1000 mg once or twice daily. It is also available as a lyophilized powder for injection in vials of 500 mg.

Chlorthalidone (klor thal' i done) is one of the most frequently used oral thiazide diuretics. It is available in tablets of 25 and 50 mg generically and under the brand name of Thalitone; recommended oral doses in adults are 25 to 100 mg once daily or 100 mg every other day.

Hydrochlorothiazide (hye' droe klor" oh thye' a zide) is available in tablets of 25 and 50 mg and as capsules of 12.5 mg generically and under the trade names of Hydrodiuril, Microzide and Esidrix; recommended oral doses in adults are 12.5 to 50 mg daily given in one or two divided doses.

Methyclothiazide (meth" i kloe thye' a zide) was previously available in tablets of 2.5 and 5 mg generically and under the trade name of Enduron; recommended oral doses in adults were 2.5 to 5 mg once daily.

Polythiazide (pol" ee thye' a zide) is available in tablets of 1, 2 and 4 mg generically and under the trade name of Renese; typical oral doses in adults are 2 to 4 mg in one or two divided doses daily.

Metolazone (me tol' a zone) is a thiazide-like diuretic that is available as tablets of 2.5 and 5 mg generically and under the trade name of Zaroxolyn; recommended oral doses in adults are 2.5 to 20 mg once daily.

Indapamide (in dap' a mide) is a thiazide-like diuretic that is available as tablets of 1.25 and 2.5 mg generically and under the trade name of Lozol; recommended oral doses in adults are 1.25 to 5 mg once daily.

The thiazide diuretics are some of the most commonly used medications and are usually well tolerated except in high doses. Common side effects of the thiazide and thiazide-like diuretics can include nausea, dizziness, headache, polyuria, dehydration, dry mouth, hyponatremia, hypokalemia and hypomagnesia. Chronic therapy may be associated with hyperuricemia and gout, hyperglycemia and hyperlipidemia, and possibly an increased risk of cholecystitis. Rare adverse reactions include pancreatitis and hypersensitivity reactions. Many of the thiazide diuretics are also available in fixed dose combination with other antihypertensive medications or with potassium-sparing diuretics.

### Hepatotoxicity

The thiazide diuretics have not been shown to cause serum aminotransferase elevations to an appreciable extent, and are often used as a control group in assessing adverse events including serum aminotransferase elevations of newer antihypertensive medications. Despite their widespread use, the thiazide diuretics have only rarely been implicated in cases of clinically apparent acute liver injury. No clear signature or clinical pattern has been demonstrated in the rare case reports and in some instances other potentially hepatotoxic medications were being used and other possible diagnoses were present. The usual latency period to onset has been short (few days to several weeks) and the pattern of serum enzyme elevations has ranged from hepatocellular, to mixed and cholestatic (Cases 1 and 2). Immunoallergic features were uncommon as was autoantibody formation. Recovery was usually rapid upon stopping. At present, only hydrochlorothiazide has been implicated in more than 3 instances, while chlorothiazide, indapamide, metolazone and polythiazide have been implicated in one or two instances in causing drug induced liver injury. Hydrochlorothiazide is the most commonly used thiazide diuretic and it is not surprising that it has been implicated most commonly. Regardless, liver injury from thiazide diuretics is exceedingly rare. The similarity in chemical structure among the thiazide diuretics suggests that liver injury might be a class effect.

Hydrochlorothiazide likelihood score: C (probable rare cause of clinically apparent liver injury).

Chlorothiazide, indapamide, metolazone and polythiazide likelihood score: D (possible rare causes of clinically apparent liver injury).

Chlorthalidone, Bendroflumethiazide, and methyclothiazide likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Some instances of hepatic injury attributed to the thiazide diuretics have appeared to be due to metabolic idiosyncrasy.

### Outcome and Management

The few instances of hepatic injury attributed to thiazide diuretics have been self-limited and rapidly reversed upon stopping the medication. There have been no convincing instances of acute liver failure or prolonged jaundice or vanishing bile duct syndrome associated with the thiazide diuretics. There have been no reports of cross challenges among the different thiazide and thiazide-like diuretics.

Drug Class: Diuretics, Thiazide Diuretics

## CASE REPORTS

### Case 1. Acute anicteric liver injury due to hydrochlorothiazide.(1)

A 72 year old woman with hypertension developed anorexia, nausea and right upper quadrant abdominal pain 6 days after starting hydrochlorothiazide. She had no history of liver disease and had normal liver tests shortly before starting therapy. She took no other medications except for calcium and did not drink alcohol or have risk factors for viral hepatitis. Physical examination demonstrated tenderness over the liver, but no jaundice. Laboratory tests showed elevations in serum aminotransferase levels, alkaline phosphatase and gamma glutamyl transpeptidase (GGT) (Table). White blood cell counts were normal. Tests for hepatitis A, B and C were negative as were autoantibodies. Liver ultrasound was normal. Hydrochlorothiazide was stopped and symptoms resolved within days. Serum aminotransferase levels were normal within two weeks and alkaline phosphatase and GGT within three weeks of stopping treatment.

#### Key Points

Medication: | Hydrochlorothiazide (25 mg daily)
Pattern: | Mixed (R=3.4)
Severity: | 1+ (enzyme elevations and symptoms)
Latency: | 6 days to onset of symptoms
Recovery: | 2-3 weeks
Other medications: | Calcium

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | GGT* (U/L) | Other
Pre | Pre | 18 | 72 | 24
0 | Hydrochlorothiazide (25 mg daily) given for 6 days
1 week | 0 | 236 | 150 | 363
3 weeks | 2 weeks | 30 | 120 | 186
4 weeks | 3 weeks | 20 | 78 | 36
5 weeks | 4 weeks | 20 | 75 | 30
Normal Values | | <41 | <140 | <60

* Values estimated from Figure 1.

#### Comment

The acute liver injury was mild but associated with symptoms arising within days of starting a low dose of hydrochlorothiazide. While the rapidity of onset suggests a hypersensitivity reaction, there were no other manifestations of an immunoallergic reaction (fever, rash, eosinophilia). Hydrochlorothiazide is one of the most frequently used medications in the world, but has only rarely been implicated in acute liver injury. Most large cases series of drug induced liver injury have not included cases attributable to thiazide diuretics.

### Case 2. Recurrent acute liver injury due to hydrochlorothiazide.(2)

A 47 year old man developed jaundice 20 days after starting hydrochlorothiazide (50 mg daily) for hypertension. He had no history of liver disease, jaundice, alcohol abuse or risk factors for viral hepatitis. He was taking no other medications. He complained of change in taste and abdominal upset, but no fever, rash or itching. Physical examination showed jaundice, but no evidence of chronic liver disease. Laboratory testing showed a total serum bilirubin of 9.5 mg/dL (direct 6.0 mg/dL) and marked elevations in serum aminotransferase levels (ALT 640 U/L, AST 1000 U/L), with minimal increase in alkaline phosphatase (5.4 Bodansky Units) and gamma glutamyl transpeptidase (60 U/L). The total white count was normal without eosinophilia. The prothrombin time and serum albumin values were normal. Tests for hepatitis B were negative as were autoantibodies. Hydrochlorothiazide was stopped and laboratory tests fell to normal within a month. Because of continuing hypertension, hydrochlorothiazide was restarted. Seventeen days later, he presented again with jaundice and serum aminotransferase levels were again elevated. A liver biopsy showed acute hepatocellular necrosis and inflammation compatible with an acute hepatitis due to a medication. Tests for hepatitis A and B and autoantibodies were negative. Hydrochlorothiazide was stopped again and laboratory values fell rapidly into the normal range. Several years later, he was seen at another medical center in another country and hydrochlorothiazide was restarted. Eighteen days later, he presented for the third time with jaundice. Stopping the medication led to improvements in laboratory tests that were normal two months later.

#### Key Points

Medication: | Hydrochlorothiazide (50 mg daily)
Pattern: | Hepatocellular (R=13)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 17-20 days to onset of jaundice on three occasions
Recovery: | 4-8 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | Hydrochlorothiazide (50 mg daily) given for 20 days
3 weeks | 0 | 640 | 5.4 | 9.5 | Admission
7 weeks | 4 weeks | Normal | Normal | Normal
0 | | Hydrochlorothiazide (50 mg daily) given for 17 days
2.5 weeks | 0 | 900 | | 5.8
9 weeks | 7 weeks | Normal | Normal | Normal
| | Hydrochlorothiazide (50 mg daily) given for 18 days
2.5 weeks | 0 | 1450 | | 8.2
10 weeks | 8 weeks | Normal | Normal | Normal
Normal Values | | <35 | <4.5 | <1.2

#### Comment

A remarkably convincing case history of recurrent acute hepatitis arising 2 to 3 weeks after starting hydrochlorothiazide for hypertension. With each exposure the pattern of injury was hepatocellular, and the clinical phenotype was a mild acute hepatitis with rapid recovery upon stopping the medication. With each reexposure, the liver injury appeared again, each time without signs of hypersensitivity (no rash, fever or eosinophilia) and without shortening of the latency or worsening of the clinical syndrome. These features suggest that metabolic idiosyncrasy rather than hypersensitivity was the cause of the hepatic injury. Despite their use in millions of patients worldwide over the previous 50 years, this is one of the only convincing published cases of hepatotoxicity from thiazide diuretics.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bendroflumethiazide – Generic, Naturetin®

Chlorothiazide – Generic, Diuril®

Chlorthalidone – Generic, Hygroton®

Hydrochlorothiazide – Generic, Esidrix®

Indapamide – Generic, Lozol®

Methyclothiazide – Generic

Metolazone – Generic, Zaroxolyn®

Polythiazide – Generic, Renese®

DRUG CLASS

Diuretics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bendroflumethiazide) (Bendroflumethiazide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bendroflumethiazide | 73-48-3 | C15-H14-F3-N3-O4-S2
Chlorothiazide | 58-94-6 | C7-H6-Cl-N3-O4-S2
Chlorthalidone | 77-36-1 | C14-H11-Cl-N2-O4-S
Hydrochlorothiazide | 58-93-5 | C7-H8-Cl-N3-O4-S2
Indapamide | 26807-65-8 | C16-H16-Cl-N3-O3-S
Methyclothiazide | 135-07-9 | C9-H11-Cl2-N3-O4-S2
Metolazone | 17560-51-9 | C16-H16-Cl-N3-O3-S
Polythiazide | 346-18-9 | C11-H13-Cl-F3-N3-O4-S3

## CITED REFERENCES

1 Arinzon Z, Alexander P, Berner Y. (2004). Hydrochlorothiazide induced hepato-cholestatic liver injury. Age Ageing.
2 Anez MS, Dickson G, Zabala R, Zabaleta P, Pacheco A, Briceno D. (1981). Gastroenterol Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 13 October 2021

Zimmerman HJ. Diuretic drugs. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 662-4. (Expert review of hepatotoxicity of diuretics published in 1999 mentions that clinically apparent liver injury due to diuretics is rare; cholestatic jaundice with features of hypersensitivity have been reported with some thiazide diuretics).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular agents, mentions that thiazide diuretics can rarely cause cholestatic hepatitis).
Jackson EK. Drugs affecting renal excretory function. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 445-70. (Textbook of pharmacology and therapeutics).
Drerup AL, Alexander WA, Lumb GD, Cummins AJ, Clark GM. (1958). Jaundice occurring in a patient treated with chlorothiazide. N Engl J Med. (62 year old woman developed pruritus within 4 days and jaundice after 14 days of starting chlorothiazide [bilirubin 17.1 mg/dL, Alk P 14.6 BU, cholesterol 990 mg/dL], biopsy showing intrahepatic cholestasis and complete recovery 2 months after stopping chlorothiazide; had hepatomegaly and xanthelasma before treatment).
Husebye KO. (1964). Jaundice with persisting pericholangiolitic inflammation in a patient treated with chlorothiazide. Report of a case. Am J Dig Dis. (58 year old woman developed jaundice after 3 years of therapy with chlorothiazide, but 10 weeks after restarting [bilirubin 6.1 mg/dL, AST 87 U/L, Alk P 8 times ULN], jaundice resolving within 6 weeks of stopping therapy, but persistent Alk P elevation and autopsy 10 months later showed periportal fibrosis and inflammation suggestive of primary biliary cirrhosis).
Weisburst M, Self T, Peace R, Cooper J. (1976). Jaundice and rash associated with the use of phenobarbital and hydrochlorothiazide. South Med J. (18 year old woman developed rash, fever and jaundice 6 weeks after starting hydrochlorothiazide and phenobarbital [bilirubin 7.2 mg/dL, AST 250 U/L, Alk P 350 U/L], resolving in 2 weeks on methylprednisolone; DRESS syndrome probably due to phenobarbital rather than diuretic).
Gangitano JL, Foster SH, Contro RM. (1978). Nonfatal methazolamide-induced aplastic anemia. Am J Ophthalmol. (83 year old man developed aplastic anemia 3 months after starting methazolamide for glaucoma; no mention of liver test abnormalities).
Butaeye P, Hubschman B, Derrien G. (1979). Nouv Presse Med. (63 year old woman developed fatigue 8 months after starting indapamide and propranolol for hypertension [bilirubin 2.4 mg/dL, ALT 412 U/L, Alk P 31 U/L], with positive lymphocyte stimulation to indapamide and resolution upon stopping).
Rosenberg L, Shapiro S, Slone D, Kaufman DW, Miettinen OS, Stolley PD. (1980). Thiazides and acute cholecystitis. N Engl J Med. (Case control study of 419 patients with acute cholecystitis and 1676 controls found increased frequency of recent use of thiazides [14% vs 8%: relative risk of 2.0]).
Porter JB, Jick H, Dinan BJ. (1981). Acute cholecystitis and thiazides. N Engl J Med. (Two case control studies; one in Boston of 176 cases of acute cholecystitis and 704 controls found no association with recent thiazide use [5% vs 4%] and similar results from study in Seattle of 70 cases and 274 controls [14% vs 15%] for an overall relative risk of 1.0).
Bourke JB, Langman MJ. (1981). Thiazide, diuretics, cholecystitis, and pancreatitis. N Engl J Med. (Case control study of 100 patients with acute pancreatitis and 100 controls found increase frequency of recent thiazide use [26% vs 11%], with highest rates in those with gallstone pancreatitis).
Anez MS, Dickson G, Zabala R, Zabaleta P, Pacheco A, Briceno D. (1981). Gastroenterol Hepatol. (47 year old man developed jaundice 20 days after starting hydrochlorothiazide without rash, fever or eosinophilia [bilirubin 9.5 mg/dL, ALT 640 U/L, Alk P 1.3 times ULN], with recurrence twice 17 and 18 days after [bilirubin 5.8 and 8.2 mg/dL, ALT 900 and 1450 U/L], resolving in 6 weeks: Case 2, thiazide diuretics).
McMaster KR, Hennigar GR. (1981). Drug-induced granulomatous hepatitis. Lab Invest. (Among 1500 liver biopsies done over 10 years, 6% had granulomas; diagnosis was sarcoidosis in 31%, tuberculosis 9%, medications 29% including methyldopa, hydralazine, metahydrin, metolazone, phenytoin, aspirin, isoniazid, cephalexin, penicillin, sulfonamides, procainamide, procarbazine, diazepam and BCPs).
Van der Linden W, Ritter B, Edlund G. (1984). Acute cholecystitis and thiazides. Br Med J(Clin Res Ed). (In a population based study, 20% of 91 patients with acute cholecystitis versus 10% of 364 controls had recently received a thiazide diuretic: relative risk of 2.1 [1.1-3.9, 95% CI]).
Kakar F, Weiss NS, Strite SA. (1986). Thiazide use and the risk of cholecystectomy in women. Am J Epidemiol. (Among female members of a group health cooperative, 25% of 153 patients undergoing gallbladder surgery were thiazide users vs 13% of 156 controls; relative risk 2.2 [1.2-4.0 95% CI]).
Hourmand-Ollivier I, Dargere S, Cohen D, Galais MP, Mosquet B, Rousselot P, Dao T. (2000). Gastroenterol Clin Biol. (69 year old woman developed hepatitis 2 months after starting the combination of benazepril and hydrochlorothiazide [bilirubin 16.3 mg/dL, ALT 30 times ULN, Alk P 2 times ULN, prothrombin index 39%], with progressive hepatic failure and death).
Gabrielli M, Gasbarrini A, Santoliquido A, Flore R, Gaetani E, Flex A, Pola P. (2001). Metolazone-induced cholestatic liver disease. Dig Liver Dis. (41 year old man with chronic heart failure developed jaundice 1-2 months after starting metolazone [bilirubin 29.6 mg/dL, ALT 86 U/L, Alk P 596 U/L], resolving within 3 weeks of stopping metolazone).
Valhovd M, Kildahl-Andersen O. (2003). Tidsskr Nor Laegeforen. (37 year old man developed jaundice 2 months after starting hydrochlorothiazide and amiloride for hypertension [bilirubin 5.8 rising to 28.3 mg/dL, ALT 2930 U/L, Alk P twice ULN, INR 1.4], with prolonged jaundice leading to 8 week course of prednisone, recovered but then developed pancytopenia: Case 1, amiloride).
Arinzon Z, Alexander P, Berner Y. (2004). Hydrochlorothiazide induced hepato-cholestatic liver injury. Age ageing. (72 year old woman developed nausea and abdominal pain 6 days after starting hydrochlorothiazide [ALT 236 U/L, Alk P 146 U/L, bilirubin not mentioned], resolving within 4 weeks of stopping: Case 1, thiazide diuretics).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 137 [0.5%] were done for idiosyncratic drug induced acute liver failure, none were attributed to a diuretic).
Leitzmann MF, Tsai CJ, Stampfer MJ, Willett WC, Giovannucci E. (2005). Thiazide diuretics and the risk of gallbladder disease requiring surgery in women. Arch Intern Med. (Analysis of thiazide diuretic use and gallbladder disease in the US Nurses’ Health Study of 81,351 women, ages 30-55 years, followed for ~20 years; found modest increase in relative risk of cholecystectomy in current users of thiazides [1.39 in multivariate analysis]).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases were identified one of which was associated with hydrochlorothiazide and one with amiloride use, but other more likely agents were being taken in both instances).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology. (Reports of drug induced liver injury to a Spanish network found 570 cases; thiazide diuretics not mentioned as cause).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; no diuretic found in the 20 most commonly implicated agents).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain calculated relative risk of injury compared to the general population: hydrochlorothiazide was being taken by 7 and furosemide by 8 patients, but relative risk was not increased in comparison to a control group).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no case was attributed to a diuretic).
(2009). Drugs for hypertension. Treat Guidel Med Lett. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities: “thiazide diuretics are the first-line therapy for many patients with hypertension”).
Björnsson E, Davidsdottir L. (2009). The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol. (Among 685 patients with drug induced liver injury, 23 [3.4%] were later hospitalized for chronic liver disease and 8 were showed to have cirrhosis, one of whom had acute icteric liver injury 3 years earlier attributed to the combination of amiloride and hydrochlorothiazide).
Gabrielli M, Gasbarrini A, Santoliquido A, Flore R, Gaetani E, Flex A, Pola P. (2001). Metolazone-induced cholestatic liver disease. Dig Liver Dis. (42 year old man with cardiomyopathy developed jaundice 3 months after starting metolazone [bilirubin 29.6 mg/dL, ALT 86 U/L, Alk P 596 U/L], resolving within 20 days of stopping metolazone while continuing warfarin or enalapril).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, none were attributed to a diuretic).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, no diuretic was mentioned among the 30 most common causes of liver injury).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which none were attributed to a diuretic).
Taglietti F, Del Nonno F, Baiocchini A, Falasca L, Pieri S, Capone A, Grilli E, et al. (2010). Acute hepatocellular and cholestatic injury during therapy with hydrochlorothiazide – clinicohistopathologic findings: a case report. J Med Case Rep. (68 year old man developed fatigue and jaundice 10 days after starting hydrochlorothiazide and olmesartan [bilirubin 6.3 rising to 14.7 mg/dL, ALT 346 U/L, Alk P 1091 U/L], resolving within 3 months of stopping both drugs).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a diuretic).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to a diuretic).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a diuretic).
(2020). Drugs for hypertension. Med Lett Drugs Ther. (Concise summary of efficacy, safety, and costs of drug therapy of hypertension including the diuretics, focusing upon relative usefulness; no mention of hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Thiazide Diuretics: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(thiazide+diuretics/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Thiazide Diuretics: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Thiazide+diuretics)